# Meprobamate

## OVERVIEW

### Introduction

Meprobamate is a sedative used for anxiety and insomnia first made available in the 1950s when it became very popular, but which is now rarely used. Meprobamate therapy was not associated with liver enzyme elevations and has not been linked to instances of clinically apparent liver injury.

### Background

Meprobamate (me" proe bam' ate) is a bis-carbamate ester which was found to have antianxiety activity and was introduced into medical use in the 1950s. Meprobamate rapidly became one of the most widely used psychotropic agents, being considered a “tranquillizer”. Commonly known by its brand name Miltown, it was approved for use in anxiety, but was widely used as a sedative and for insomnia. The sedative effects of meprobamate resemble those of the benzodiazepines, and it is known to bind to the GABA-A receptor. However, the precise mechanism of action of meprobamate is unclear. Meprobamate also has major abuse potential and many cases of dependency, habituation and overdose have been described. Withdrawal can lead to hallucinations and seizures. Meprobamate was approved for use in generalized anxiety disorders in the United States in 1955, but it is currently rarely used and is classified as a Schedule IV controlled substance because of its potential for abuse and dependency. Nevertheless, meprobamate remains available in several generic forms as 200 and 400 mg tablets. In addition, the muscle relaxant carisoprodol is a prodrug of meprobamate and is clinically available, although now it is also classified as a Schedule IV controlled substance [January 2012]. The recommended dosage of meprobamate is 1200 to 1600 mg daily in three or four divided doses. Side effects may include diarrhea, nausea, flatulence, drowsiness, ataxia, dizziness, headache, weakness, nervousness, euphoria, overstimulation and physical dependence. Uncommon but potentially severe adverse reactions include hypersensivity reactions including Stevens Johnson syndrome, embryo-fetal toxicity, addiction and dependence, stupor, coma and death from overdose.

### Hepatotoxicity

Rates of serum enzyme elevations during meprobamate therapy have not been reported. While instances of clinically apparent liver injury due to meprobamate have been mentioned in review articles, no cases with specific information on clinical features have appeared in the published literature. Thus, meprobamate may be capable of causing clinically apparent liver injury, but it must be rare. Meprobamate is metabolized in the liver via the cytochrome P450 system and has major potential for drug-drug interactions. Meprobamate can exacerbate symptoms of porphyria. Serious allergic reactions to meprobamate have been reported including Stevens Johnson syndrome. In cases of meprobamate overdose, the cause of death has been respiratory suppression and not liver failure, although liver histology was not well defined.

Likelihood score: E* (unproven but suspected cause of liver injury).

Drug Class: Sedatives and Hypnotics, Miscellaneous

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Meprobamate – Generic

DRUG CLASS

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Meprobamate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Meprobamate | 57-53-4 | C9-H18-N2-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 21 January 2020

Zimmerman HJ. Psychotropic and anticonvulsant agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-516. (Expert review of hepatotoxicity published in 1999; mentions that there have been three reported instances of liver injury attributed to meprobamate, but clinical features are not specifically discussed).
Kanel GC. Histopathology of drug-induced liver disease. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, p. 284. (Meprobamate is listed as causing cholestasis with inflammation, but is not specifically discussed).
Mihic SJ, Mayfield J, Harris RA. Hypnotics and sedatives. In, Brunton LL, Chabner BA Hillal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 339-54. (Textbook of pharmacology and therapeutics).
Selling LS. (1955). Clinical study of a new tranquilizing drug; use of miltown(2-methyl-2-n-propyl-1,3-propanediol dicarbamate). J Am Med Assoc. (Among 187 patients with anxiety treated with meprobamate in a private practice, 64 recovered, 88 were improved, 35 were not improved and 3 patients developed allergic reactions; states that meprobamate "is not habit forming", but does not mention liver complications).
Friedman HT, Marmelzat WL. (1956). Adverse reactions to meprobamate. J Am Med Assoc. (Description of 7 cases of severe adverse events due to meprobamate, including rash [n=5], ocular palsy and severe diarrhea; no mention of liver injury).
Ewing JA, Fullilove RE. (1957). Addiction to meprobamate. N Engl J Med. (32 year old man taking 4 to 8 g of meprobamate daily developed headaches, muscle twitching, anxiety and somatic complaints during withdrawal).
Haizlip TM, Ewing JA. (1958). Meprobamate habituation: a controlled clinical study. N Engl J Med. (75 residents of a State mental hospital were given meprobamate [3.2 and 6.4 g daily] or placebo for 40 days and then "surreptitiously" switched to placebo; withdrawal symptoms included insomnia, anxiety, tremors, nausea, hallucinations, acute psychosis and convulsions; no hepatic complications mentioned).
Cowger ML, Labbe RF. (1965). Contraindications of biological-oxidation inhibitors in the treatment of porphyria. Lancet. (Mentions that clinical relapses of acute intermittent porphyria have occurred with drugs other than barbiturates, including chlordiazepoxide and meprobamate).
Ayd FJ. (1964). Meprobamate: A decade of experience. Psychosomatics. (Review of the safety and efficacy of meprobamate after a decade of its wide scale clinical use; states "that meprobamate is free from hepatotoxicity is incontrovertible").
Maddock RK, Bloomer HA. (1967). Meprobamate overdosage. Evaluation of its severity and methods of treatment. JAMA. (10 patients with meprobamate overdose [1.6 to 30 g], ages 16 to 48 years, 7 women, 8 in coma, 1 died; plasma levels correlated with coma state and there was rapid renal clearance; no mention of liver injury).
Schwartz HS. (1976). Acute meprobamate poisoning with gastrotomy and removal of a drug-containing mass. N Engl J Med. (56 year old woman developed coma and respiratory failure after overdose of 36 g of meprobamate, with persistent high levels in serum, gastroscopy demonstrating a mass of undigested meprobamate tablets in the stomach, ultimately requiring surgical removal; no mention of liver injury).
Crome P, Higgenbottom T, Elliott JA. (1977). Severe meprobamate poisoning: successful treatment with haemoperfusion. Postgrad Med J. (56 year old woman with meprobamate overdose developed coma and respiratory depression, improved by hemoperfusion with charcoal column; no mention of liver injury).
Kintz P, Tracqui A, Mangin P, Lugnier AA. (1988). Fatal meprobamate self-poisoning. Am J Forensic Med Pathol. (35 year old man found dead with lethal levels of meprobamate in blood; no description of liver histology).
Littrell RA, Sage T, Miller W. (1993). Meprobamate dependence secondary to carisoprodol (Soma) use. Am J Drug Alcohol Abuse. (37 year old woman was found to have meprobamate on urine screening after a motor vehicle accident, but denied taking meprobamate, but did admit to use of carisoprodol which she was later found to regularly abuse).
Bailey DN, Briggs JR. (2002). Carisoprodol: an unrecognized drug of abuse. Am J Clin Pathol. (Over a 6 month period, 19 patients were found to have carisoprodol in urine on comprehensive drug screens, 12 with decrease in level of consciousness; liver injury not mentioned).
Buire AC, Vitry F, Hoizey G, Lamiable D, Trenque T. (2009). Overdose of meprobamate: plasma concentration and Glasgow Coma Scale. Br J Clin Pharmacol. (Among 59 cases of meprobamate overdose, plasma levels correlated roughly with degree of coma; only one patient died).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to meprobamate).
Fathallah N, Zamy M, Slim R, Fain O, Hmouda H, Bouraoui K, Ben Salem C, Biour M. (2011). Acute pancreatitis in the course of meprobamate poisoning. JOP. (43 year old woman took an overdose of meprobamate [60 g] and was admitted in stupor and found to have pancreatitis [bilirubin 1.0 mg/dL, ALT 65 U/L, Alk P 115 U/L, lipase 21.3 times ULN], resolving with temporary ventilator support and hydration).
Herzberg D. (2011). Blockbusters and controlled substances: Miltown, Quaalude, and consumer demand for drugs in postwar America. Stud Hist Philos Biol Biomed Sci. (History of discovery, approval, marketing and subsequent wide scale use and abuse of meprobamate).
Reeves RR, Burke RS, Kose S. (2012). Carisoprodol: update on abuse potential and legal status. South Med J. (Review of the clinical features and frequency of carisoprodol abuse which increased between 2001 and 2008 and decreased with the introduction of restrictions on its sale; carisoprodol was classified as a schedule IV controlled substance in the US starting in January 2012).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to meprobamate).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to sedatives, meprobamate or carisoprodol).

## OTHER REFERENCE LINKS

1 Recent References on Meprobamate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Meprobamate/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Meprobamate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Meprobamate)